# Ethionamide

## OVERVIEW

### Introduction

Ethionamide is a second line drug in the therapy of tuberculosis used only in combination with other agents and for drug-resistant tuberculosis. Ethionamide has been linked to transient, asymptomatic elevations in serum aminotransferase levels and in uncommon instances of acute liver injury, which can be severe.

### Background

Ethionamide (eth" eye on' a mide) is a thio-isonicotinamide somewhat similar in structure to isoniazid. Ethionamide is a prodrug and, like isoniazid, requires activation whereupon it inhibits mycobacterial fatty acid synthesis (enoyl-ACP reductase) that is necessary for cell wall synthesis and repair. Interestingly, there is little cross resistance between isoniazid and ethionamide, probably because they are activated by different mycobacterial enzymes, and therefore can be used together. Ethionamide is currently used only as a secondary agent in the treatment of active tuberculosis, always in combination with other antituberculosis agents such as isoniazid, ethambutol, pyrazinamide and/or rifampin and usually for multidrug resistant mycobacterial infections or in situations where first line agents are contraindicated. Ethionamide also has activity against lepromatous leprosy. Ethionamide is available as 250 mg tablets in generic forms and under the brand name Trecator. The typical dose in adults is 250 mg twice daily, but can then be increased gradually to a total dose of 15 to 20 mg/kg per day to a maximum of 1 gram given either once or in two divided doses daily. Pyridoxine (vitamin B6: 50 mg daily) is usually administered with ethionamide. Common side effects include gastrointestinal upset, nausea, anorexia, diarrhea, metallic taste, stomatitis, depression, drowsiness and fatigue. Severe adverse events include mycobacterial resistance, hypersensitivity reactions and severe cutaneous reactions including Stevens Johnson syndrome, toxic epidermal necrolysis and DRESS syndrome.

The management of multidrug resistant tuberculosis is challenging and should be under the direction of physicians with expertise in tuberculosis therapy and management of its side effects. Optimal regimens of therapy for tuberculosis are complex and change frequently. Regularly updated recommendations on use of drugs for tuberculosis, including indications, contraindications, warnings, dosages and monitoring recommendations are available at the Centers for Disease Control and Prevention website: http://www.cdc.gov/tb/publications/guidelines/Treatment.htm.

### Hepatotoxicity

Ethionamide therapy has been linked to elevations in serum aminotransferase levels in a proportion of patients, but these elevations are typically self-limited and asymptomatic. More importantly, ethionamide has been linked to many instances of clinical apparent acute liver injury that arise in up to 5% of patients and can be severe and even fatal. The time to onset and clinical features of hepatic injury due to ethionamide resemble those of isoniazid, the latency ranging from 2 weeks to more than 6 months after starting (most arise within 1 to 3 months), and the pattern of enzyme elevations typically being hepatocellular and resembling acute viral hepatitis. Features of hypersensitivity (rash, fever and eosinophilia) are uncommon. Like isoniazid, ethionamide therapy may be associated with development of autoantibodies (typically ANA), but titers are generally low and rarely accompanied by autoimmune conditions. Cases of severe hypersensitivity reaction including Stevens Johnson Syndrome and DRESS which can be accompanied by liver injury have been described with ethionamide.

Likelihood score: B (highly likely although rare cause of clinically apparent liver injury).

### Mechanism of Injury

Ethionamide is extensively metabolized by the liver and liver injury likely is due to a toxic or immunologically active intermediate. Rapid recurrence of injury upon rechallenge suggests a hypersensitivity reaction.

### Outcome and Management

Serum aminotransferase elevations during ethionamide therapy are generally transient and asymptomatic, but elevations accompanied by symptoms of hepatitis and those above five times ULN should lead to prompt discontinuation. Monitoring of serum aminotransferase levels is indicated in patients with underlying liver disease receiving ethionamide and in those with a high risk of developing hepatotoxicity. Some cases of ethionamide hepatotoxicity have been severe and fatal instances have been reported. Cross reactivity to hepatic injury between isoniazid and ethionamide has not been shown, and several patients with clinically apparent liver injury due to ethionamide have later tolerated isoniazid without difficulty.

[First line medications used in the therapy of tuberculosis in the US include ethambutol, isoniazid, pyrazinamide, rifabutin, rifampin, and rifapentine. Second line medications include streptomycin, capreomycin, cycloserine, ethionamide, pretomanid, fluoroquinolones such as levofloxacin and moxifloxacin, aminoglycosides such as amikacin, and para-aminosalicylic acid (PAS).]

Drug Class: Antituberculosis Agents

Other Drugs in the Class: Bedaquiline, Capreomycin, Cycloserine, Ethambutol, Isoniazid, Pretomanid, Pyrazinamide, Rifabutin, Rifampin, Rifapentine, Streptomycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ethionamide – Trecator®

DRUG CLASS

Antituberculosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ethionamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ethionamide | 536-33-4 | C8-H10-N2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 16 December 2020

Abbreviations: DRESS, drug rash with eosinophilia and systemic symptoms; HIV, human immunodeficiency virus; MAC, Mycobacterium avium complex; PAS, para-aminosalicylic acid; SJS, Stevens Johnson syndrome; TEN, toxic epidermal necrolysis.

Zimmerman HJ. Antituberculosis agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 611-21. (Extensive review of hepatotoxicity of antituberculosis medications including ethambutol published in 1999; mentions that ethionamide has been reported to cause liver injury in 3-5% of patients).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs).
Gumbo T. Chemotherapy of tuberculosis, mycobacterium avium complex disease and leprosy. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1067-86. (Textbook of pharmacology and therapeutics).
Clarke GBM, O'Hea AJ. (1961). Chronic pulmonary tuberculosis treatment with ethionamide combined with cycloserine or oxytetracycline. Br Med J. (Among 12 patients with drug resistant tuberculosis treated with ethionamide and either cycloserine or oxytetracycline, 1 developed jaundice after 14 weeks [peak bilirubin 12 mg/dL, Alk P 3 times ULN], which was attributed to ethionamide and resolved 3 months after stopping).
Slavin P. (1962). Ethionamide in re-treatment of eleven patients with pulmonary tuberculosis. Am Rev Respir Dis. (Experience in treating 11 patients with drug resistant tuberculosis using ethionamide in combination with multiple agents; 2 patients developed liver injury, but both improved with stopping pyrazinamide while continuing ethionamide).
Phillips S, Trevathan RD. (1962). Serum glutamic oxaloacetic transaminase elevation and possible hepatotoxicity accompanying the administration of ethionamide. Am Rev Respir Dis. (49 patients with tuberculosis had AST testing during ethionamide therapy; 2 developed elevations at 2 and 6 months, peak levels 83 and 215 U/L, mild symptoms but no jaundice).
Moulding TS, Goldstein S. (1962). Hepatotoxicity due to ethionamide. Am Rev Respir Dis. (33 year old man developed jaundice 8 months after starting ethionamide and 6 months after blood transfusions [bilirubin 5.8 mg/dL, AST 520 U/L, Alk P 3 times ULN], improving on stopping and worsening again on restarting ethionamide; later tolerated isoniazid without recurrence; discusses 12 further cases in the literature).
Petty TL, Mitchell RS. (1962). Successful treatment of advanced isoniazid- and streptomycin-resistant pulmonary tuberculosis with ethionamide, pyrazinamide, and isoniazid. Am Rev Respir Dis. (Among 70 patients with isoniazid or streptomycin resistance treated with ethionamide, 12 developed AST elevations, but abnormalities were attributed to pyrazinamide; one patient died of liver failure but was also taking isoniazid and pyrazinamide and drinking heavily).
Phillips S, Tashman H. (1963). Ethionamide jaundice. Am Rev Respir Dis. (59 year old man developed abnormal liver tests 5 weeks after starting ethionamide and streptomycin for active tuberculosis which worsened by 8 weeks [bilirubin 3.2 mg/dL, AST 1170 U/L, Alk P normal], resolving rapidly on stopping and not recurring subsequently with streptomycin and isoniazid therapy).
Lees AW. (1963). Jaundice due to ethionamide. Br J Dis Chest. (3 of 62 patients with tuberculosis treated with ethionamide developed jaundice; all 3 were women, ages 54 to 72 years with onset 1-4 months after starting ethionamide in combination with either isoniazid or streptomycin [peak bilirubin 3.0-5.8 mg/dL, Alk P 2-3 times ULN], resolving after 1-4 months; one had positive rechallenge with ethionamide; all later tolerated isoniazid without recurrence).
El-Khoury SA, Dunmore LA. (1964). Ethionamide and hepatotoxicity: a clinical study. Med Ann Dist Columbia. (Analysis of hepatotoxicity in 40 patients with tuberculosis treated with ethionamide for 4-14 months [750 mg daily] in various combinations; 3 patients had BSP elevations, but ALT and AST were normal or minimally elevated and none developed jaundice or Alk P elevations).
Conn HO, Binder HJ, Orr HD. (1964). Ethionamide-induced hepatitis. A review with a report of an additional case. Am Rev Respir Dis. (35 year old man with tuberculosis and multiple relapses, developed fatigue 6 weeks after starting ethionamide and cycloserine, improving on stopping and redeveloping symptoms 1 week after restarting [bilirubin 0.7 mg/dL, AST 500, Alk P 6 times ULN], resolving rapidly on stopping ethionamide only; biopsy showed centrolobular necrosis).
Nagasawa J, Mikami R. (1964). The side effects of ethionamide with emphasis on its hepatotoxicity. Bull Int Union Tuberc. (Two Japanese women with tuberculosis, ages 34 and 57 years, developed acute liver failure after 1.5 and 7 months of ethionamide therapy, whose autopsies showed massive necrosis; among 50 patients studied prospectively, 36% were said to develop abnormal liver tests, based on serial BSP, icterus index and cephalin-flocculation).
Aquinas SM. (1964). Reactions to antituberculosis drugs among Chinese in Hong Kong. Tubercle. (Among 389 patients treated with pyrazinamide and ethionamide for tuberculosis, side effects requiring discontinuation of therapy occurred in 4 [1%], including 3 with jaundice [all attributed to pyrazinamide], one of whom died).
De Voogd A. (1964). Rev Tuberc Pneumol (Paris). (5 year old girl with tuberculosis developed jaundice 3 months after starting isoniazid, ethionamide and PAS [ALT 750 U/L; interpreted as viral hepatitis], all three agents being restarted after recovery and patient tolerated final 3 months of therapy).
Schwartz WS. (1966). Comparison of ethionamide with isoniazid in original treatment cases of pulmonary tuberculosis. XIV. A report of the Veterans Administration—Armed Forces cooperative study. Am Rev Respir Dis. (Controlled trial of ethionamide vs isoniazid with streptomycin in 236 patients with active tuberculosis; similar efficacy but higher rate of toxicity with ethionamide [39% vs 11% requiring discontinuation], jaundice appearing in 1 [1%] and abnormal AST levels in 10 patients [~10%] on ethionamide).
Byrd RB, Kaplan PD, Gracey DR. (1974). Treatment of pulmonary tuberculosis. Chest. (Review of therapy of tuberculosis; ethionamide is discussed as potentially causing hepatitis).
Rossouw JE, Saunders SJ. (1975). Hepatic complications of antituberculous therapy. Q J Med. (Summary of hepatic complications among 7492 cases of tuberculosis treated between 1960 and 1973 using various antituberculosis regimens; among 38 cases of hepatitis [0.3%] with 5 deaths from hepatic failure, 3 were associated with ethionamide therapy, specific details on these three were not given).
Pattyn SR, Janssens L, Bourland J, Saylan T, Davies EM, Grillone S, Feracci C. (1984). Hepatotoxicity of the combination of rifampin-ethionamide in the treatment of multibacillary leprosy. Int J Lepr Other Mycobact Dis. (Among 596 patients with leprosy treated with rifampin and ethionamide [and either dapsone or clofazimine], 23 [4.5%] developed hepatitis arising after 5-186 days [mean 93 days], with mortality of 26% attributed to drug combination).
See A, Hervio P, Bouvry M. (1986). Ann Gastroenterol Hepatol (Paris). (22 year old man with leprosy and HBsAg carrier state developed jaundice and pruritus 2 years after starting thalidomide, rifampin, ethionamide and clofazimine [bilirubin 6.4 mg/dL, ALT 15 times ULN, Alk P 287 U/L, prothrombin index 60%], recovering within 4-5 months of stopping ethionamide and rifampin).
Donald PR, Schoeman JF, O'Kennedy A. (1987). Hepatic toxicity during chemotherapy for severe tuberculosis meningitis. Am J Dis Child. (Among 56 children with tuberculosis meningitis treated with isoniazid, rifampin, pyrazinamide and ethionamide, ALT elevations occurred in 72%, but only one child developed jaundice which was attributed to hepatitis A).
Donald PR, Schoeman JF, Van Zyl LE, De Villiers JN, Pretorius M, Springer P. (1998). Intensive short course chemotherapy in the management of tuberculous meningitis. Int J Tuberc Lung Dis. (Among 95 children with tuberculous meningitis treated with a 6 month course of isoniazid, rifampin, pyrazinamide and ethionamide, 10 developed elevated bilirubin levels during 2-4 weeks of therapy, but these resolved with or without stopping therapy; one child had hepatitis A, and 14% had transient AST or ALT elevations).
American Thoracic Society, Centers for Disease Control and Prevention (CDC). (2003). Infectious Diseases Society of America. Treatment of tuberculosis. MMWR Recomm Rep. (Recommendations for therapy of tuberculosis including details of drug regimens, side effects, monitoring and optimal approaches to follow up; ethionamide is a second line agent).
Di Perri G, Bonora S. (2004). Which agents should we use for the treatment of multidrug-resistant Mycobacterium tuberculosis?. J Antimicrob Chemother. (Multidrug resistance is defined as an organism resistant to at least isoniazid and rifampin; authors rank second line agents as: 1. levofloxacin, aminoglycosides, and capreomycin, 2. ethionamide, ofloxacin and ciprofloxacin, 3. PAS, 4. cycloserine, 5. amoxicillin/clavulanate or ampicillin/sulbactam, 6. clarithromycin, linezolid and clofazimine).
Fajardo TT, Guinto RS, Cellona RV, Abalos RM, Dela Cruz EC, Gelber RH. (2006). A clinical trial of ethionamide and prothionamide for treatment of lepromatous leprosy. Am J Trop Med Hyg. (Among 46 patients with leprosy treated with either ethionamide or prothionamide for 6 months, elevations in AST [35-88 U/L] occurred in 18 [39%], often resolving despite continuing medication, and only one patient developed jaundice [on prothionamide]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, no case was attributed to ethionamide).
(2008). Ethionamide. Tuberculosis (Edinb). (Brief review of the structure, mechanism of action, resistance, efficacy and safety of ethionamide).
Abubakar I, Moore J, Drobniewski F, Kruijshaar M, Brown T, Yates M, Anderson C, et al. (2009). Extensively drug-resistant tuberculosis in the UK: 1995 to 2007. Thorax. (Among 678 extensively drug resistant isolates of tuberculosis reported in the UK between 2005 and 2008, 14% were also resistant to ethionamide).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 25 to antituberculosis agents, including 15 to isoniazid alone [ranking first], 6 to isoniazid combined with other agents, 3 to rifampin and pyrazinamide and 1 to dapsone, but none to ethionamide).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, 181 [58%] were attributed to antituberculosis agents which accounted for 39 of 54 [72%] fatal cases; ethionamide is not specifically mentioned).
Arbex MA, Varella Mde C, Siqueira HR, Mello FA. (2010). Antituberculosis drugs: drug interactions, adverse effects, and use in special situations. Part 2: second line drugs. J Bras Pneumol. (Analysis of adverse effects of second line drugs for tuberculosis; states that hepatotoxicity occurs in 4.3% of patients treated with ethionamide, especially in those with liver disease or alcoholism).
Caminero JA, Sotgiu G, Zumla A, Migliori GB. (2010). Best drug treatment for multidrug-resistant and extensively drug-resistant tuberculosis. Lancet Infect Dis. (Mentions that ethionamide is a thioamide and belongs to the second line of antituberculosis medications; no discussion of hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 2 [2%] of which were attributed to antituberculosis agents, 1 isoniazid and 1 rifampin but none to ethionamide).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 13 [7%] due to antituberculosis agents including 6 to isoniazid, 1 to pyrazinamide, 1 to rifampin and 5 to combinations).
Bhushan B, Chander R, Kajal NC, Ranga V, Gupta A, Bharti H. (2014). Profile of adverse drug reactions in drug resistant tuberculosis from Punjab. Indian J Tuberc. (Among 207 patients from Punjab, India with tuberculosis treated with second line agents over a 2 year period, 81% developed adverse events which were severe in 35 [18%], 5 of which were hepatitis which was usually attributed to pyrazinamide; ethionamide was associated with 6 cases of hypothyroidism and 6 of acute psychosis that led to at least temporary discontinuation).
Lehloenya RJ, Muloiwa R, Dlamini S, Gantsho N, Todd G, Dheda K. (2015). Lack of cross-toxicity between isoniazid and ethionamide in severe cutaneous adverse drug reactions: a series of 25 consecutive confirmed cases. J Antimicrob Chemother. (Among 69 patients [62 with HIV co-infection] who developed a severe cutaneous reaction while on combination antituberculosis therapy, 20 had recurrence when reexposed to isoniazid and 5 when reexposed to ethionamide; most had been initially exposed to both agents, but none had cross reactivity to the other, those with positive rechallenge to isoniazid being able to tolerate ethionamide and vice versa).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 54 [6%] were attributed to antituberculosis agents including 48 to isoniazid, 2 to rifampin, 2 [0.2%] to pyrazinamide, 1 to ethambutol and 1 to isoniazid and rifampin, but none to ethionamide).
Bright-Thomas RJ, Gondker AR, Morris J, Ormerod LP. (2016). Drug-related hepatitis in patients treated with standard anti-tuberculosis chemotherapy over a 30-year period. Int J Tuberc Lung Dis. (Among 2070 patients with tuberculosis treated over a 30 year period at a single UK referral center, 63 [3%] developed hepatitis requiring discontinuation of therapy of whom two died; the hepatitis rate was higher in whites than Asians and in females than males, and occurred more commonly with older age; 57% of cases were attributed to pyrazinamide, 32% to rifampin and 11% to isoniazid; ethionamide not mentioned).
Ramachandran G, Swaminathan S. (2015). Safety and tolerability profile of second-line anti-tuberculosis medications. Drug Saf. (Review of the safety of second line drugs for tuberculosis mentions that the major adverse events with ethionamide therapy are gastrointestinal intolerance and hypothyroidism, but mentions rare events include hepatitis, rash, hypoglycemia, central nervous system effects and gynecomastia).
Thee S, Garcia-Prats AJ, Donald PR, Hesseling AC, Schaaf HS. (2016). A review of the use of ethionamide and prothionamide in childhood tuberculosis. Tuberculosis (Edinb). (Review of the mechanism of action, clinical efficacy and safety of ethionamide in children with active tuberculosis mentions that adverse effects of hypothyroidism and gastrointestinal upset are common).
Xu M, Bhatt DK, Yeung CK, Claw KG, Chaudhry AS, Gaedigk A, Pearce RE, et al. (2017). Genetic and nongenetic factors associated with protein abundance of flavin-containing monooxygenase 3 in human liver. J Pharmacol Exp Ther. (Flavin-containing monooxygenase 3 is a human liver microsomal enzyme responsible for the activation of ethionamide and exists in variable concentrations in human livers, levels determined to some extent by genetic variation).
Dheda K, Gumbo T, Maartens G, Dooley KE, Murray M, Furin J, Nardell EA, Warren RM. (2019). Lancet Respiratory Medicine drug-resistant tuberculosis Commission group. The Lancet Respiratory Medicine Commission: 2019 update: epidemiology, pathogenesis, transmission, diagnosis, and management of multidrug-resistant and incurable tuberculosis. Lancet Respir Med. (Review of the epidemiology, pathogenesis, diagnosis and management of multidrug resistant tuberculosis; does not discuss hepatotoxicity of therapeutic drug regimens).
Borisov S, Danila E, Maryandyshev A, Dalcolmo M, Miliauskas S, Kuksa L, Manga S, et al. (2019). Surveillance of adverse events in the treatment of drug-resistant tuberculosis: first global report. Eur Respir J. (Among 658 patients enrolled in a prospective registry of adverse events attributed to second line antituberculosis therapies, 3 serious liver related adverse events were reported including one due to ethionamide and 2 to bedaquiline).
CDC. https://www.cdc.gov/tb/ (CDC website with up-to-date recommendations on therapy of tuberculosis).

## OTHER REFERENCE LINKS

1 Recent References on Ethionamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ethionamide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ethionamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ethionamide)